# Crofelemer

## OVERVIEW

### Introduction

Crofelemer is an antidiarrheal agent derived from the red sap of the South American plant Croton lechleri, which is used to treat noninfectious diarrhea in HIV positive patients on antiretroviral therapy. Crofelemer is associated with occasional instances of serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent acute liver injury.

### Background

Crofelemer (kroe fel' e mer) is a botanical antidiarrheal agent that is used to treat noninfectious diarrhea in HIV seropositive patients taking antiretroviral medications. Crofelemer is derived from the red sap of the South American plant Croton lechleri, which has been used for centuries to treat diarrheal illness. The active antidiarrheal product in crofelemer appears to be a large macromolecular, oligomeric proanthocyanidin which has been shown to decrease chloride secretion in the intestine by inhibition of the cystic fibrosis transmembrane conductance regulator (CFTR), as well as calcium-activated chloride channels. In large clinical trials, daily therapy with crofelemer was found to decrease watery bowel movements and improve stool consistency in patients with HIV infection receiving antiretroviral therapy, and who had persistent diarrhea that could not be attributed to an infectious cause. Crofelemer was approved for use in the United States in 2013, the first herbal medication to be approved for a specific medical use and first agent approved for therapy of noninfectious diarrhea in HIV positive patients. Crofelemer is available in tablets of 125 mg under the commercial name Mytesi. The typical dose is one tablet twice daily. Side effects are uncommon and generally mild, but can include flatulence, bloating, nausea, constipation, increased bilirubin, cough and symptoms of upper respiratory illness.

### Hepatotoxicity

During long term use of crofelemer in preregistration studies, serum ALT elevations occurred in 2.7% of treated subjects, but the background rate of serum enzyme elevations in this population was not defined in these open label studies. The elevations were generally mild and self-limited, rarely leading to dose reduction or discontinuation of therapy. There have been no reports of clinically apparent liver injury attributable to crofelemer, although it has had only limited wide scale use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which crofelemer might lead to serum enzyme elevations or liver injury is not known. Very little of the agent is absorbed systematically and, although it can be metabolized by the hepatic cytochrome P450 system, there is little evidence that adequate levels are achieved during oral therapy to cause clinically significant drug-drug interactions with other agents. In clinical trials of crofelemer, no evidence of drug-drug interactions was identified.

### Outcome and Management

Serum enzyme elevations during crofelemer therapy are generally mild and self-limited, resolving even without drug interruption or dose reduction. Other causes of liver injury should be sought before assuming that the abnormalities are due to crofelemer.

Drug Class: Gastrointestinal Agents; Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Crofelemer – Mytesi®

DRUG CLASS

Antidiarrheal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Crofelemer)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Crofelemer | 148465-45-6 | Unspecified | Crofelemer Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 November 2017

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; crofelemer is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; crofelemer is not discussed).
Tradtrantip L, Namkung W, Verkman AS. Crofelemer, an antisecretory antidiarrheal oligomer extracted from Croton lechleri, targets two distinct intestinal chloride channels. Mol Pharmacol 2010; 77: 69-78. (Investigation of the antidiarrheal mechanism of action of crofelemer found that it inhibited two different chloride channels [CFTR and calcium-activated chloride channels] in vitro in human intestinal cell lines). 19808995
MacArthur RD, Hawkins TN, Brown SJ, LaMarca A, Clay PG, Barrett AC, Bortey E, et al. Efficacy and safety of crofelemer for noninfectious diarrhea in HIV-seropositive individuals (ADVENT trial): a randomized, double-blind, placebo-controlled, two-stage study. HIV Clin Trials 2013; 14: 261-73. (Among 374 adults with HIV infection and noninfectious diarrhea attributed to antiretroviral therapy enrolled in a two stage, placebo controlled study of different doses of crofelemer, serum levels were undetectable in 96% of patients and adverse event rates were similar to those of placebo; during an open label extension study, serum ALT elevations occurred in 2.7% of crofelemer treated subjects, but all resolved and there were no serious adverse hepatic events or instances of clinically apparent liver injury). 19808995
Crofelemer (Fulyzaq) for antiretroviral-induced diarrhea. Med Let Drug Therap 2013; 55 (1421): 59-60. (Concise review of the mechanism of action, efficacy, safety and costs of crofelemer as therapy of noninfectious diarrhea in patients with HIV infection taking antiretroviral agents mentions that adverse events are uncommon and mild; no mention of ALT elevations or hepatotoxicity). 23863919
Frampton JE. Crofelemer: a review of its use in the management of non-infectious diarrhea in adult patients with HIV/AIDS on antiretroviral therapy. Drugs 2013; 73: 1121-9. (Systematic review of the literature on the mechanism of action, efficacy and safety of crofelemer in noninfectious diarrhea among antiretroviral treated adults with HIV infection, mentions that adverse events were uncommon and mild, but could include flatulence [3.1%], abdominal distention [1/7%], constipation [1.7%], dyspepsia [1.3%], nausea [1.3%] and ALT elevations [1.3%]). 23807722

## OTHER REFERENCE LINKS

1. Recent References on Crofelemer: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Crofelemer/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Crofelemer: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Crofelemer)